# Multiple Sclerosis Agents

## OVERVIEW

Multiple sclerosis is a chronic demyelinating disorder of the central nervous system of unknown etiology. It is most likely caused by a gradual, intermittent autoimmune destruction of myelin. The disorder is characterized by a relapsing-remitting course, but in a small proportion of patients, it is unremittingly progressive even from the onset. The disease typically presents between the ages of 20 and 40 years and is more common in women than men. Rates of multiple sclerosis vary geographically, being highest in Northern parts of Europe and the United States and in Canada. Multiple sclerosis affects an estimated 400,000 persons in the United States and is the most common cause of neurologic disability in young adulthood.

Therapies of multiple sclerosis can be divided into disease modifying agents and symptomatic therapies. The disease modifying agents are largely immunomodulatory drugs including interferon beta-1a (Avonex, 1994 and Rebif, 2003), interferon beta-1b (Betaseron and Extavia, 1993), peginterferon beta-1a (Plegridy, 2014), glatiramer acetate (Copaxone and Glatopa 1996), alemtuzumab (Lemtrada, 2001), natalizumab (Tysabri, 2004), mitoxantrone (generic, 2006), fingolimod (Gilenya, 2010), teriflunomide (Aubagio, 2012), three fumarates (dimethyl fumarate: Tecfidera, 2013; diroximel fumarate: Vumerity, 2019; and monomethyl fumarate: Bafiertam, 2020), ocrelizumab (Ocrevus, 2017), daclizumab (Zinbryta, 2017; withdrawn 2018), cladribine (Mavenclad, 2019), siponimod (Mayzent, 2019), ozanimod (Zeposia, 2020) and ponesimod (Ponvory, 2021). Disease modifying agents that are used in resistant cases of multiple sclerosis some of which are not specifically approved for this use (off-label use) include methotrexate, cyclophosphamide, and intravenous immunoglobulins. The disease modifying agents are more effective in relapsing-remitting forms of disease than in the more severe and intractable progressive forms. Symptomatic therapies developed for multiple sclerosis include dalfampridine (4-aminopyrine; Ampyra, 2010), a potassium channel blocker that improves mobility and walking speed in patients with relapsing-remitting forms of multiple sclerosis. For acute flares of multiple sclerosis, high doses of corticosteroids are used, particularly a 3 to 5 days course of high dose methylprednisolone.

While transient, asymptomatic and mild-to-moderate serum aminotransferase elevations occur not uncommonly with most of the drugs used to treat multiple sclerosis, clinically apparent hepatotoxicity is rare. Nevertheless, several convincing instances of acute liver injury have been reported for the various forms of interferon beta, glatiramer acetate, dimethyl fumarate, alemtuzumab, daclizumab, and fingolimod. Importantly, clinically apparent liver injury was usually first attributed to these agents several years after their introduction, and initially they were not believed to be hepatotoxic. Thus, many of the more recently introduced agents (fingolimod, siponimod, ozanimod, ponesimod, teriflunomide, cladribine, and the fumarates) have not had wide enough general use to state that they do not cause clinically apparent liver injury, and all have been associated occasionally with marked but transient increases in serum aminotransferase levels.

The following agents are discussed individually in LiverTox.

Disease Modifying Agents
Generic Name Brand Name | Type of Agent | Approval for MS | Indication Type of MS | Route and Regimen | Likelihood Score
Alemtuzumab Campath | mAb to CD-52 | 2001 | RRMS, SPMS | iv [3 or 5 days] every 12 months | B
Cladribine Mavenclad | Purine Antimetabolite | 2017 | RRMS, SPMS | oral daily in two 4- to 5-day courses | D
Daclizumab Zinbryta | mAb to IL2 Receptor | 2017 Withdrawn | RRMS | sc once monthly | B
Dimethyl Fumarate Tecfidera | Nrf2 Activator | 2013 | RRMS, SPMS, CIS | oral twice daily | C
Diroximel Fumarate Vumerity* | Nrf2 Activator | 2019 | RRMS, SPMS, CIS | oral twice daily | E*
Monomethyl Fumarate Bafiertam* | Nrf2 Activator | 2020 | RRMS, SPMS, CIS | oral twice daily | E*
Fingolimod Gelenya | S1P Receptor Modulator | 2010 | RRMS, SPMS, CIS | oral once daily | C
Glatiramer Acetate Glatopa | Amino Acid Polymers | 1996 | RRMS, SPMS, CIS | sc daily or thrice weekly | B
Interferon beta-1a Avonex, Rebif | Recombinant Cytokine | 1996 | RRMS, SPMS, CIS | im weekly sc thrice weekly | A
Interferon beta-1b Betaseron, Extavia | Recombinant Cytokine | 1993 | RRMS, SPMS, CIS | sc every other day | A
Peginterferon beta-1a Plegridy | Pegylated Rec Cytokine | 2014 | RRMS, SPMS, CIS | sc every 2 weeks | A
Mitoxantrone Generic | Cytotoxic Antibiotic | 2006 | RRMS, SPMS | iv every 3 months | D
Natalizumab Tysabri | mAb to α4β1 integrin | 2005 | RRMS, CIS, SPMS | iv every 4 weeks | B
Ocrelizumab Ocrevus | mAb to CD-20 | 2017 | RRMS, CIS, SPMS, PPMS | iv every 6 months | C
Ozanimod Zeposia | S1P Receptor Modulator | 2020 | RRMS, CIS, SPMS | oral daily | E*
Ponesimod Ponvory | S1P Receptor Modulator | 2021 | RRMS, CIS, SPMS | oral daily | E*
Siponimod Mayzent | S1P Receptor Modulator | 2019 | RRMS, CIS, SPMS | oral daily | E*
Teriflunomide Aubagio | Pyrimidine Syn Inhibitor | 2012 | RRMS, CIS, SPMS | oral daily | C
Symptomatic Therapy
Generic Name Brand Name | Type of Agent | Approval | Indication | Route and Regimen | Likelihood Score
Dalfampridine Ampyra | Pyrimidine Analogue | 2010 | RRMS | oral twice daily | E
Methylprednisolone; Solu-Medrol | Corticosteroid | 1957 | Acute Flare | iv daily for 3-5 days | A

Abbreviations: CIS, clinically isolated syndrome; mAb, monoclonal antibody; MS, multiple sclerosis; PPMS, primary progressive multiple sclerosis; RRMS, relapsing, remitting multiple sclerosis; S1P, sphingosine-1-phosphate; SPMS, active secondary progressive multiple sclerosis.

Administration Routes: im, intramuscular; iv, intravenous; sc, subcutaneous.

*Described in chapter on Dimethyl Fumarate.

## ANNOTATED BIBLIOGRAPHY

References updated: 12 December 2025

Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999, the drugs for multiple sclerosis are not discussed, the majority having been developed and introduced into clinical medicine since 1999).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss the drugs for multiple sclerosis).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-51. (Textbook of pharmacology and therapeutics).
Interferon beta-1B for multiple sclerosis. Med Lett Drugs Ther 1993; 35(900): 61-2. (Concise review of mechanism of action, efficacy, safety and costs of interferon beta-1b shortly after its approval for use in multiple sclerosis in the US, mentions that it is generally well tolerated; no mention of ALT elevations or hepatotoxicity). 8515719
Interferon beta-1A for relapsing multiple sclerosis. Med Lett Drugs Ther 1996; 38(979): 63-4. (Concise review of efficacy and safety of interferon beta-1a [Avonex] shortly after its approval for multiple sclerosis in the US, mentions side effects of flu-like symptoms, injection site reactions, but does not mention ALT elevations or hepatotoxicity). 8692073
Glatiramer acetate for relapsing multiple sclerosis. Med Lett Drugs Ther 1997; 39(1004): 61-2. (Concise review of mechanism of action, efficacy, safety and costs of glatiramer acetate for relapsing multiple sclerosis shortly after its approval in the US, mentions injection reactions [local and systemic], but that "no hematological or hepatic toxicity has been detected"). 9217693
Beta interferons for multiple sclerosis. Med Lett Drugs Ther 2002; 44(1141): 88-9. (Concise review of efficacy, safety and costs of 3 forms of interferon beta for multiple sclerosis mentions that serum enzyme abnormalities were more frequent with Betaseron [beta-1b] and Avonex [beta-1a] than with Rebif [beta-1a], but does not mention clinically apparent liver injury). 12381969
Natalizumab (Tysabri) for relapsing multiple sclerosis. Med Lett Drugs Ther 2005; 47(1202): 13-5. (Concise review of mechanism of action, efficacy, safety and costs of natalizumab [humanized monoclonal antibody to integrin] shortly after its approval for this indication in the US, mentions hypersensitivity reactions and neutralizing antibody, but not ALT elevations or clinically apparent liver injury; this agent was withdrawn from the market one year later because of progressive multifocal leukoencephalopathy [PML]). 15711498
Alemtuzumab (Compath) off-label for relapsing multiple sclerosis. Med Lett Drugs Ther 2009; 51(1307): 17-8. (Discussion of the off label use of alemtuzumab [humanized monoclonal antibody to CD52] for relapsing multiple sclerosis, mentions that side effects include infusion reactions, autoimmune thyroid disorders and thrombocytopenic purpura, but does not mention ALT elevations or clinically apparent hepatotoxicity). 19265776
Interferon beta-1b (Extavia) for multiple sclerosis. Med Lett Drugs Ther 2010; 52: 86-7. (Concise review of efficacy and safety of interferon beta-1b [Extavia] shortly after its approval in the US, mentions that hepatic enzyme elevations may occur). 21045760
Oral fingolimod (Gilenya) for multiple sclerosis. Med Lett Drugs Ther 2010; 52(1353-1354): 98-9. (Concise review of mechanism of action, efficacy, safety and costs of fingolimod shortly after is approval for use for multiple sclerosis in the US, mentions that common side effects are headache, cough, diarrhea, back pain and aminotransferase elevations; no mention of clinically apparent liver injury). 21344782
Dalfampridine (Ampyra) for MS. Med Lett Drugs Ther 2010; 52(1347): 73-4. (Concise review of the mechanism of action, efficacy, safety and costs of dalfampridine shortly after its approval in the US, mentions common side effects were urinary tract infection, insomnia, dizziness, headache, nausea, fatigue, back pain and ataxia; no mention of ALT elevations or hepatotoxicity). 20847716
Gold R. Oral therapies for multiple sclerosis: a review of agents in phase III development or recently approved. CNS Drugs 2011; 25: 37-52. (Review of the mechanism of action, efficacy and safety of 5 new, oral therapies of multiple sclerosis, mentions serum enzyme elevations occurring in 8.5-12.5% of fingolimod treated vs 1.7% on placebo, and at an increased rate with teriflunomide). 21128693
Killestein J, Rudick RA, Polman CH. Oral treatment for multiple sclerosis. Lancet Neurol 2011; 10: 1026-34. (Review of the clinical usefulness and safety of 5 new oral therapies for relapsing multiple sclerosis, mentions that liver enzyme elevations can occur with teriflunomide and fingolimod therapy). 22014437
New drugs for relapsing multiple sclerosis. Med Lett Drugs Ther 2012; 54(1403): 89-91. (Concise review of efficacy, safety and costs of new disease modifying drugs for multiple sclerosis lists side effects in a table including "transaminase elevations" for interferon beta, fingolimod and teriflunomide, and "hepatotoxicity" for natalizumab, but not for glatiramer or mitoxantrone). 23183318
Dimethyl fumarate (Tecfidera) for multiple sclerosis. Med Lett Drugs Ther 2013; 55(1418): 45-7. (Concise review of mechanism of action, efficacy, safety and costs of dimethyl fumarate for multiple sclerosis shortly after its approval in the US mentions side effects of flushing, abdominal pain, nausea and lymphopenia, but not ALT elevations or hepatotoxicity). 24662841
Oh J, O'Connor PW. Safety, tolerability, and efficacy of oral therapies for relapsing-remitting multiple sclerosis. CNS Drugs 2013; 27: 591-609. (Review of new oral therapies for multiple sclerosis lists elevated serum enzymes as occurring with fingolimod, teriflunomide, dimethyl fumarate and laquinimod). 23801528
Peginterferon beta-1a (Plegridy) for multiple sclerosis. Med Lett Drugs Ther 2015; 57(1468): 67-9. (Concise review of efficacy, safety and costs of peginterferon beta-1a shortly after its approval for use in multiple sclerosis in the US, mentions that injection site reactions and influenza-like symptoms are common adverse effects, but does not mention ALT elevations or hepatotoxicity). 25941954
Pawate S, Bagnato F. Newer agents in the treatment of multiple sclerosis. Neurologist 2015; 19: 104-17. (Summary of the efficacy and safety of new drugs for multiple sclerosis mentions that fingolimod, laquinimod and teriflunomide have been associated with serum enzyme elevations during treatment, but no specifics given). 25888198
English C, Aloi JJ. New FDA-approved disease-modifying therapies for multiple sclerosis. Clin Ther 2015; 37: 691-715. (Systematic review of efficacy and safety of the newer disease modifying therapies of multiple sclerosis, lists ALT elevations as adverse events associated with fingolimod, teriflunomide and dimethyl fumarate, but not peginterferon beta or alemtuzumab). 25846320
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to interferon beta, but none were linked to other drugs used for multiple sclerosis). 25754159
Feinstein A, Freeman J, Lo AC. Treatment of progressive multiple sclerosis: what works, what does not, and what is needed. Lancet Neurol 2015; 14: 194-207. (Commentary on management of progressive multiple sclerosis in which most of the newer disease modifying agents have little effect, stresses that major attention should be paid to management and relief of symptoms such as fatigue, bladder dysfunction, spasticity, pain, depression and cognitive dysfunction; no discussion of liver related adverse effects of medications). 25772898
Drugs for multiple sclerosis. Med Lett Drugs Ther 2016; 58(1496): 71-4. (Concise review of the mechanism of action, clinical efficacy, safety, costs and relative role of the medications approved for use in multiple sclerosis mentions that beta interferon and natalizumab can cause clinically apparent liver injury and that fingolimod and teriflunomide are associated with frequent serum enzyme elevations). 27249095
Daclizumab (Zinbryta) for multiple sclerosis. Med Lett Drugs Ther 2016; 58(1503): 117-9. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of daclizumab shortly after its approval for use in multiple sclerosis mentions that it has many safety concerns and should be reserved for patients who do not respond to first line therapies and that hepatotoxicity, autoimmune reactions and serum aminotransferase elevations are potential adverse events). 27603962
Siponimod (Mayzent)--a new drug for multiple sclerosis. Med Lett Drugs Ther 2019; 61(1571): 70-2. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of siponimod, the second sphingosine-1 receptor modulator approved for use in multiple sclerosis; mentions that it is associated with serum ALT elevations and patients should have routine liver tests and have CYP 2C9 genotyping before starting). 31169805
Cladribine (Mavenclad) for multiple sclerosis. Med Lett Drugs Ther 2019; 61(1577): 118-20. (Concise review of the mechanism of action, clinical efficacy, safety and costs of cladribine, mentions that patients should be tested for hepatitis B and C before starting cladribine because of concerns over reactivation). 31381552
Holmøy T, Fevang B, Olsen DB, Spigset O, Bø L. Adverse events with fatal outcome associated with alemtuzumab treatment in multiple sclerosis. BMC Res Notes 2019; 12: 497. (Systematic review of fatal adverse events associated with alemtuzumab therapy of multiple sclerosis identified 9 fatal instances one of which was autoimmune hepatitis that arose 15 months after starting therapy). 31405369
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640. PIMD: 30230957. (Among 4873 cases of severe liver injury attributed to agents used to treat multiple sclerosis reported to the FDA’s Adverse Event Reporting System between 2004 and 2016, the most frequently implicated agents were interferon-beta 1a [n=2343], natalizumab [n=759], interferon beta 1b [535], fingolimod [496], dimethyl fumarate [223], glatimer acetate [212], teriflunomide [158], mitoxantrone [199], and alemtuzumab [93].
Butzkueven H, Kappos L, Wiendl H, Trojano M, Spelman T, Chang I, Kasliwal R, et al.; Tysabri Observational Program (TOP) Investigators. Long-term safety and effectiveness of natalizumab treatment in clinical practice: 10 years of real-world data from the Tysabri Observational Program (TOP). J Neurol Neurosurg Psychiatry 2020;91(6): 660-8. (A long term observational study enrolled 6148 patients from 17 countries with multiple sclerosis as they started natalizumab with follow up for up to 11 years [median=5.2 years]; 829 patients [13.5%] had at least one serious adverse event including progressive multifocal leukoencephalopathy in 53 [0.9%], malignancy in 66 [1.1%] and hepatic events in 12 [0.2%] described as drug induced liver injury in 4, autoimmune hepatitis in 2 and acute liver failure, fulminant hepatitis, hepatitis and liver injury in 1 each: no specific details given). 32234967
Ozanimod (Zeposia) for multiple sclerosis. Med Lett Drugs Ther 2020; 62(1605): 132-4. (Concise review of the mechanism of action, clinical efficacy, toxicity and costs of ozanimod shortly after its approval for use in relapsing multiple sclerosis in the US mentions that ozanimod is associated with ALT and AST elevations and that therapy lowers lymphocyte counts and increases the risk of infections including herpes zoster). 32970043
Lu MC, Shih YL, Hsieh TY, Lin JC. Flare of hepatitis B virus after fingolimod treatment for relapsing and remitting multiple sclerosis. J Formos Med Assoc 2020; 119: 886-7. (Letter describing 41 year old Taiwanese woman with relapsing multiple sclerosis and inactive HBsAg carrier state who developed reactivation of hepatitis B after 35 months of treatment with fingolimod [ALT 385 U/L, HBV DNA 8 log_10_ IU/mL, bilirubin not given], who responded to tenofovir with resolution of ALT elevations and decrease of HBV DNA levels to undetectable despite continuation of fingolimod). 31679907
Markham A. Ponesimod: first approval. Drugs 2021; 81: 957-62. (Review of the mechanism of action, development, clinical efficacy and safety of ponesimod shortly after its approval in the US in 2021, mentions that serum aminotransferase elevations occurred in 23% of ponesimod recipients in one large preregistration trial). 33939119
Drugs for multiple sclerosis. Med Lett Drugs Ther 2021; 63(1620): 42-8. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
McGinley MP, Goldschmidt CH, Rae-Grant AD. Diagnosis and treatment of multiple sclerosis: a review. JAMA. 2021;325:765-779.. (Review of the clinical features, diagnosis, and therapy of multiple sclerosis, discusses nine classes of disease modifying therapies almost all of which share a risk of hepatotoxicity). 33620411
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880. (Extensive review of the pre- and postmarketing data on hepatotoxicity of disease modifying therapies of relapsing forms of multiple sclerosis, none of which are completely free of the potential of hepatotoxicity, including interferon beta, glatiramer, fingolimod, teriflunomide, dimethyl fumarate, cladribine, natalizumab, alemtuzumab and ocrelizumab). 34319570
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407